# Demeclocycline

## OVERVIEW

### Introduction

Demeclocycline is a tetracycline antibiotic derived from a mutant strain of Streptomyces aureofaciens that is used for infections due to susceptible microorganisms, but perhaps more frequently, used off label as an inhibitor of the renal action of vasopressin in the therapy of hyponatremia due to the syndrome of inappropriate secretion of antidiuretic hormone (SIADH). While demeclocycline has not been linked specifically to liver injury in the published literature, it is an orally available tetracycline and is likely to cause liver injury similar to that described for other oral tetracyclines, such as minocycline and doxycycline. Because it is uncommonly used, its potential for causing liver injury may not have been fully defined.

### Background

Demeclocycline (dem" e kloe sye' kleen) is a tetracycline antibiotic that is used for therapy of mild-to-moderate infections caused by susceptible organisms. More frequently it has been used off label as therapy of hyponatremia due to the syndrome of inappropriate secretion of antidiuretic hormone (SIADH). Its mechanism of action in SIADH is not well understood, but it appears to block the renal action of arginine vasopressin (antidiuretic hormone: ADH) and induce a renal diabetes insipidus. This inhibition of ADH action causes an increase in the excretion of free water without an accompanying increase in sodium loss, which results in aquaresis and an increase in serum sodium concentration. Too high of a dose, however, can result in hypernatremia, dehydration, and renal dysfunction. Demeclocycline was approved for use as an antibiotic for a wide spectrum of microorganisms in the United States in 1959. It is available as tablets of 150 or 300 mg generically and previously under the commercial name of Declomycin. The recommended dose for infections is 600 mg daily in two to four divided doses. Doses used for SIADH are 600 to 1200 mg daily. Common side effects include indigestion, nausea, diarrhea, headache, dizziness, glossitis and rash. Potentially serious adverse events include photosensitivity, intracranial hypertension (pseudotumor cerebri), hypersensitivity reactions, and staining of developing teeth and inhibition of bone growth (in children or when taken by a pregnant mother) for which reason the tetracyclines should not be used in pregnant women or in children below the age of nine. Demeclocycline can also cause a worsening of renal function, particularly in patients with underlying renal or hepatic disease. Its use as an antibiotic has been replaced by more effective and better tolerated tetracyclines such as doxycycline and minocycline. It is also no longer considered a first line of therapy for SIADH.

### Hepatotoxicity

No reports of clinically apparent liver injury with symptoms or jaundice due to demeclocycline have been published. However, demeclocycline is a tetracycline derivative and is likely to cause liver injury similar to other oral tetracyclines such as minocycline and doxycycline. Both hepatitis and liver failure are mentioned in the product label for demeclocycline, but details of the liver injury are not provided. Finally, demeclocycline can cause worsening of kidney function in patients with cirrhosis and should not be used for hyponatremia associated with chronic liver disease.

Likelihood score: E* (suspected but unproven cause of clinically apparent liver injury).

Drug Class: Antiinfective Agents, Tetracyclines

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Demeclocycline – Generic, Declomycin®

DRUG CLASS

Antiinfective Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=demeclocycline)

Product labeling at DailyMed, National Library of Medicine, NIH.

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Demeclocycline Hydrochloride | 64-73-3 | C21-H21-Cl-N2-O8.Cl-H

## ANNOTATED BIBLIOGRAPHY

References updated: 15 June 2026

Abbreviations used: ULN, upper limit of normal; SIADH, syndrome of inappropriate secretion of antidiuretic hormone.
Zimmerman HJ. Tetracyclines. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. p. 599-602. (Expert review of tetracycline and liver injury published in 1999; the tetracyclines cause two forms of drug induced liver injury, microvesicular fat and liver failure occurring after 4-10 days with high doses of parenteral tetracyclines and an idiosyncratic liver injury that occurs with the oral agents, doxycycline typically causing a cholestatic and minocycline a hepatocellular injury which may be associated with autoimmune features).
Moseley RH. Tetracyclines. Hepatotoxicity of antimicrobials and antifungal agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, p. 468. (Expert review of tetracycline induced liver injury mentions that the hepatotoxicity of intravenous tetracycline is of historic interest only as it is no longer given parenterally; both doxycycline and minocycline have been associated with idiosyncratic liver injury).
MacDougall C. Protein synthesis inhibitors and miscellaneous antibacterial agents. In, Brunton LL, Hilal-Dandan R, Kollmann BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1049-65. (Textbook of pharmacology and therapeutics).
Tetracyclines and the liver in pregnancy. Lancet 1966; 1: 357-8. (Editorial on the history of acute fatty liver of pregnancy, first described by Sheehan in 1940 and later linked to high dose iv tetracycline in pregnancy, but also in nonpregnant women and in men). 4159865
Combes B, Whalley PJ, Adams RH. Tetracycline and the liver. Prog Liver Dis 1972; 4: 589-96. (Review of hepatotoxicity of tetracycline, including studies of pathogenesis). 4569011
Carrilho F, Bosch J, Arroyo V, Mas A, Viver J, Rodes J. Renal failure associated with demeclocycline in cirrhosis. Ann Intern Med 1977; 87: 195-7. (Treatment of hyponatremia in the presence of cirrhosis and ascites with demeclocycline led to worsening renal function without improvement in hyponatremia in all 3 patients studied). 407825
Forrest JN Jr, Cox M, Hong C, Morrison G, Bia M, Singer I. Superiority of demeclocycline over lithium in the treatment of chronic syndrome of inappropriate secretion of antidiuretic hormone. N Engl J Med. 1978;298:173-7. (Among 10 patients with hyponatremia due to the syndrome of inappropriate secretion of antidiuretic hormone [SIADH: 7 with carcinoma, 2 with brain injury, 1 idiopathic] treatment with demeclocycline [600 to 1200 mg daily] restored serum sodium levels and allowed for unrestricted water intake within 5 to 14 days, and chronic treatment led to long term control with no renal impairment or mention of liver injury). 413037
Carson JL, Strom BL, Duff A, et al. Acute liver disease associated with erythromycins, sulfonamides, and tetracyclines. Ann Intern Med 1993; 119 (7 Pt 1): 576-83. (Case control study using Medicaid billing results between 1980-87 found 107 cases of hospitalization for unexplained hepatitis, odds ratios for erythromycin 5.2; sulfonamides 11.4; tetracyclines 5.2; total of 5 cases exposed to tetracycline, doxycycline or minocycline). 8363168
Friis H, Andreasen PB. Drug-induced hepatic injury: an analysis of 1100 cases reported to the Danish Committee on Adverse Drug Reactions between 1978 and 1987. J Intern Med 1992; 232: 133-8. (Adverse drug reaction reports between 1978 and 1987 in Denmark; no tetracycline is mentioned as a cause). 1506809
Pillans PI. Drug associated hepatic reactions in New Zealand: 21 years’ experience. N Z Med J 1996; 109: 315-9. (Adverse drug reaction reports identified 943 liver injuries over 21 years in New Zealand; triacetyloleandomycin accounted for 21 cases [2.1%] and minocycline for at least 4). 8816722
Björnsson E, Lindberg J, Olsson R. Liver reactions to oral low-dose tetracyclines. Scand J Gastroenterol 1997; 32: 390-5. Review. PMID: 9140164 (32 year old man developed abdominal pain, dark urine and rash within 24 hours of starting doxycycline which he had received in the past [bilirubin 4.3- 8.1 mg/dL, ALT 3.5 times ULN, Alk P 1.1 times ULN], resolving within 3 months of stopping; thorough review of all published and SADRAC reported cases of oral tetracycline associated liver injury found 15 cases, only 6 rated as likely, none with tetracycline, 5 doxycycline, 1 lymecycline).
Goh KP. Management of hyponatremia. Am Fam Physician 2004; 69: 2387-94. (Review of the causes, diagnosis and management of hyponatremia and SIADH, with discussion of use of demeclocycline). 15168958
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl 2004; 10: 1018-23. (Among ~50,000 liver transplants done in the US between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, none of which were attributed to minocycline, doxycycline or tetracycline). 15390328
Björnsson E, Jerlstad P, Bergqvist A, Olsson R. Fulminant drug-induced hepatic failure leading to death or liver transplantation in Sweden. Scand J Gastroenterol 2005; 40: 1095-101. (Among 103 cases of fulminant drug induced liver injury reported to a Swedish registry between 1966 and 2002, one case was attributed to doxycycline, but no other tetracycline mentioned). 16165719
Heaton PC, Fenwick SR, Brewer DE. Association between tetracycline or doxycycline and hepatotoxicity: a population based case-control study. J Clin Pharm Ther 2007; 32: 483-7. (Analysis of 2 years of Medicaid claims in California found 3377 cases of “hepatotoxicity”; 20 had received tetracycline <45 days before onset; only 4 controls had: adjusted odds ratio 3.7; not elevated for doxycycline; this despite safety record of oral tetracyclines and known hepatotoxicity of doxycycline). 17875115
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, et al; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, minocycline accounted for 3 cases, doxycycline for 3 cases, and tetracycline was listed as a secondary possible cause for one; no case was attributed to demeclocycline). 18955056
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury including 25 to antituberculosis agents, 9 to trimethoprim/sulfamethoxazole, 12 to nitrofurantoin, 2 to doxycycline, but none to minocycline or other tetracyclines such as demeclocycline). 20949552
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. [PMC free article (https://www.ncbi.nlm.nih.gov/pmc/articles/PMC4446235/)] [] (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 323 [36%] were attributed to antibiotics including 28 [3%] to minocycline and 4 [0.4%] to doxycycline, but none to demeclocycline). 25754159
Miell J, Dhanjal P, Jamookeeah C. Evidence for the use of demeclocycline in the treatment of hyponatraemia secondary to SIADH: a systematic review. Int J Clin Pract. 2015;69:1396-417. (Critical review of the literature on efficacy of demeclocycline for hyponatremia of the syndrome of inappropriate secretion of antidiuretic hormone suggests that demeclocycline has a variable efficacy and safety profile and requires careful monitoring). 26289137
Singh A, Dass B, Ejaz A, Bali A. Long-term use of demeclocycline for the treatment of chronic hyponatremia. Cureus. 2019;11:e6415. (76 year old man with symptomatic hyponatremia and SIADH had a prompt response to oral demeclocycline that was sustained during 11 months of follow up without adverse events). 31988816
Wei C, Liu Y, Jiang A, Wu B. A pharmacovigilance study of the association between tetracyclines and hepatotoxicity based on Food and Drug Administration adverse event reporting system data. Int J Clin Pharm. 2022;44:709-716. [] (Analysis of tetracyclines in the FDA’s Adverse Event Reporting System [FAERS] from 2004 to 2020, identified 1435 cases of liver injury, the most being with minocycline [n=547], doxycycline [545], tigecycline [288], and tetracycline [41] with few to omadacycline [4], oxytetracycline [3], eravacycline [2], sarecycline [2], and demeclocycline [1]; no clinical details provided). 35364753
Iwahori K, Nii T, Yamaguchi N, Kawasaki T, Okamura S, Hashimoto K, Matsuki T, et al. A randomized phase 2 study on demeclocycline in patients with mild-to-moderate COVID-19. Sci Rep. 2023;13:13809. (Among 20 hospitalized adults with mild-to-moderate COVID-19 who were treated with demeclocycline [150 or 300 mg daily] or control therapy for 14 days, there were no differences in complications or outcomes of SARS-CoV-2 infection and therapy was well tolerated, treatment-related adverse events being rash and diarrhea; no mention of ALT elevations or liver injury). 37612352
Bessone F, Hernandez N, Medina-Caliz I, García-Cortés M, Schinoni MI, Mendizabal M, Chiodi D, et al. Drug-induced liver injury in Latin America: 10-year experience of the Latin American DILI (LATINDILI) Network. Clin Gastroenterol Hepatol. 2025;23:89-102. (Among 468 cases of idiosyncratic drug induced liver injury enrolled in a prospective Latin American database, 4 [0.9%] were attributed to minocycline, 1 [0.2%] each to doxycycline and tetracycline, but none to demeclocycline, eravacycline, omadacycline, sarecycline, or tigecycline). 38992407

## OTHER REFERENCE LINKS

1. Recent References on Demeclocycline: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=demeclocycline/AE+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI+OR+hepatitis,+toxic%5BMH%5D)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Demeclocycline: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=demeclocycline)